# Omadacycline

## OVERVIEW

### Introduction

Omadacycline is a tetracycline-class antibiotic used to treat moderate-to-severe infections including community-acquired pneumonia and acute bacterial skin and skin structure infections caused by susceptible organisms. Omadacycline use has been associated with low rates of serum enzyme elevations during therapy but has not been implicated in cases of clinically apparent acute liver injury.

### Background

Omadacycline (oh mad" a sye' kleen) is a broad-spectrum tetracycline class antibiotic with potent activity against both aerobic and anaerobic, gram-positive and gram-negative organisms. Omadacycline is a semisynthetic derivative of minocycline that is classified as an aminomethylcycline. It has a broader spectrum of activity than standard tetracyclines including activity against tetracycline-resistant organisms and methicillin-resistant Staphylococcus aureus (MRSA). Omadacycline also has excellent oral absorption, and both intravenous and oral preparations have been developed. In multiple clinical trials, omadacycline was found to be effective in community acquired pneumonia and serious acute skin and skin structure associated infections (cellulitis, abscess, deep tissue infections). The tetracyclines act by inhibition of protein synthesis by binding to the 30S subunit of microbial ribosomes. Human cells are less susceptible to this inhibition. Omadacycline was approved in the United States for use in community acquired pneumonia and skin and skin structure infections in adults in 2018. It is available as 100 mg of lyophilized powder in single dose vials for reconstitution and intravenous use as well as 150 mg tablets for oral use under the brand name Nuzyra. Omadacycline is generally given as a loading dose initially, followed by a daily intravenous or oral maintenance dose for a total of 7 to 14 days. Side effects of omadacycline include gastrointestinal upset, nausea and diarrhea, and more rarely, rash and hypersensitivity reactions. Tetracyclines can cause vertigo and tinnitus, skin photosensitivity reactions, intracranial hypertension (pseudotumor cerebri), Clostridioides difficile associated diarrhea, and staining of developing teeth and inhibition of bone growth (in children or when taken by a pregnant mother) for which reason the tetracyclines should not be used in pregnant women or in children below the age of nine.

### Hepatotoxicity

In pre-registration clinical trials of omadacycline usually conducted in critically ill patients with major infections, serum aminotransferase elevations above 3 times the upper limit of normal occurred in 4.3% of patients, above 5 times ULN in 2.1%, and above 10 times ULN in 0.9%. The abnormalities were generally transient and asymptomatic and were no more frequent than with comparator antibiotics (linezolid, moxifloxacin). In clinical trials that included over 1,000 patients treated with omadacycline, there were no cases of clinically apparent liver injury attributable to the drug. A single patient was considered to have serious liver injury, but it arose after cardiac arrest and appeared to be due to ischemia rather than a drug.

Nevertheless, other tetracycline antibiotics are well known causes of drug induced liver injury. In particular, high doses of intravenous tetracycline are known to cause severe hepatic microvesicular steatosis with lactic acidosis and severe hepatic dysfunction (LASH syndrome) for which reason intravenous tetracycline has been withdrawn from use. This complication has not been reported with intravenous omadacycline but liver injury with similar clinical features have occurred with intravenous tigecycline, particularly when given for more than 10 days. The oral tetracyclines have also been linked to idiosyncratic liver injury with autoimmune features that generally arise with long term use and have most commonly been associated with minocycline. This complication also has not been reported with omadacycline, eravacycline or tigecycline which are given for short periods only (7 to 10 days).

Likelihood score: E* (unproven but suspected cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which omadacycline might cause liver injury is unknown. Omadacycline is not metabolized in the liver to an appreciable extent which may explain its relative lack of hepatotoxicity. It does not appear to interact with cytochrome P450 enzymes and has not been reported to cause significant drug-drug interactions with inducers or inhibitors of these enzymes.

### Outcome and Management

Patients on omadacycline who develop serum aminotransferase elevations that rise above 5 times the upper limit of normal or are accompanied by jaundice or symptoms should have omadacycline discontinued. Whether there is cross sensitivity to hepatic injury among the various tetracyclines is not known, but switching to another class of antibiotics would be more appropriate than changing to another tetracycline-like agent in patients who develop significant hepatic injury while receiving omadacycline.

Drug Class: Antiinfective Agents, Tetracyclines

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Omadacycline – Nuzyra®

DRUG CLASS

Antiinfective Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/drugInfo.cfm?setid=51591524-4703-44c6-8bde-dce3e6a463d1)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Omadacycline | 389139-89-3 | C29-H40-N4-O7

## ANNOTATED BIBLIOGRAPHY

References updated: 15 June 2026

Abbreviations used: ULN, upper limit of normal.

Zimmerman HJ. Tetracyclines. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. p. 599-602. (Expert review of tetracycline and liver injury published in 1999 long before the availability of omadacycline; the tetracyclines cause two forms of drug induced liver injury, microvesicular fat and liver failure occurring after 4-10 days with high doses of parenteral tetracyclines and an idiosyncratic liver injury that occurs with the oral agents, doxycycline typically causing a cholestatic and minocycline a hepatocellular injury which may be associated with autoimmune features).
Moseley RH. Tetracyclines. Hepatotoxicity of antimicrobials and antifungal agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, p. 468. (Expert review of tetracycline induced liver injury; mentions that the hepatotoxicity of intravenous tetracycline is of historic interest only as it is no longer given parenterally; both doxycycline and minocycline have been associated with idiosyncratic liver injury; omadacycline and eravacycline are not mentioned).
MacDougall C. Protein synthesis inhibitors and miscellaneous antibacterial agents. In, Brunton LL, Hilal-Dandan R, Knollmann BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1049-65. (Textbook of pharmacology and therapeutics).
https://www.accessdata.fda.gov/scripts/cder/daf/ (FDA Drug Approvals website that has product labels [package inserts], letters of approval and full FDA scientific review of the new drug application for safety and efficacy; mentions serious adverse events associated with omadacycline are consistent with those seen with other tetracyclines and the most frequent were nausea, vomiting, infusion site reactions ALT elevations, headache, insomnia and diarrhea; ALT elevations occurred in 3.7-4.1% of omadacycline- vs 3.6% in linezolid- and 4.6% in moxifloxacin-treated subjects, and no subject developed clinically apparent liver injury with jaundice that could be attributed to omadacycline).
Noel GJ, Draper MP, Hait H, Tanaka SK, Arbeit RD. A randomized, evaluator-blind, phase 2 study comparing the safety and efficacy of omadacycline to those of linezolid for treatment of complicated skin and skin structure infections. Antimicrob Agents Chemother 2012; 56: 5650-4. (Among 219 adults with complicated skin and skin structure infections treated with omadacycline vs linezolid, clinical response rates were similar [97% vs 93%] as were adverse event rates, ALT elevations occurring in 3% of both groups). 22908151
Markham A, Keam SJ. Omadacycline: first global approval. Drugs 2018; 78: 1931-7. (Review of the mechanism of action, history of development, pharmacology, clinical efficacy, and safety of omadacycline shortly after its first approval for use in the US; mentions that ALT or AST elevations arose in 3-4% of patients treated with omadacycline but that similar rates were reported in patients on comparator antibiotic regimens). 30471003
Omadacycline (Nuzyra)--a new tetracycline antibiotic. Med Lett Drugs Ther. 2019;61(1572):74-77. (Concise review of the mechanism of action, clinical efficacy, safety, and costs of omadacycline shortly after its approval for use in the United States mentions that it can cause nausea, vomiting, diarrhea, constipation, headache, hypertension, insomnia, and hepatic transaminase elevations and warns of serious tetracycline-related adverse events). 31169800
Opal S, File TM, van der Poll T, Tzanis E, Chitra S, McGovern PC. An integrated safety summary of omadacycline, a novel aminomethylcycline antibiotic. Clin Infect Dis. 2019;69(Suppl 1):S40-S47. (Review of safety of omadacycline focusing upon the 1073 patients in phase 3 randomized controlled trials in which adverse events arose in 48% vs 41%-49% with comparator antibiotics, which were serious in 3.6% vs 1.9%-6.7%, ALT elevations above 3 times ULN in 4.3% vs 4.1%-4.5%, above 5 times in 2.1% vs 0.8%-1.0%, above 10 times in 0.9% vs 0.5%-0.3%, and with no case of treatment-related clinically apparent liver injury). 31367740
Kovacs SJ, Ting L, Praestgaard J, Sunkara G, Sun H, Stein DS, Tanaka SK et al. An open-label study of the impact of hepatic impairment on the pharmacokinetics and safety of single oral and intravenous doses of omadacycline. Antimicrob Agents Chemother. 2020;64:e01650-20. (Among 30 adults undergoing single dose pharmacokinetic studies, there were no differences in area-under-the-curve drug concentrations or in adverse events in patients with mild, moderate, or severe hepatic dysfunction compared to healthy controls). 32839218
Wei C, Liu Y, Jiang A, Wu B. A pharmacovigilance study of the association between tetracyclines and hepatotoxicity based on Food and Drug Administration adverse event reporting system data. Int J Clin Pharm. 2022;44:709-716. [] (Analysis of tetracyclines in the FDA’s Adverse Event Reporting System [FAERS] over a 16 year period, identified 1435 cases of liver injury, the most being with minocycline [n=547], doxycycline [545], tigecycline [288], and tetracycline [41] with few to omadacycline [4], oxytetracycline [3], eravacycline [2], sarecycline [2], and demeclocycline [1]; no details provided). 35364753
Bessone F, Hernandez N, Medina-Caliz I, García-Cortés M, Schinoni MI, Mendizabal M, Chiodi D, et al. Drug-induced liver injury in Latin America: 10-year experience of the Latin American DILI (LATINDILI) Network. Clin Gastroenterol Hepatol. 2025;23:89-102. (Among 468 cases of idiosyncratic drug-induced liver injury enrolled in a prospective Latin American database, 4 [1%] were attributed to minocycline, 1 [0.2%] each to doxycycline and tetracycline but none to eravacycline, omadacycline, sarecycline, or tigecycline). 38992407
Liu J, Liu J, Li H, Pang J, Chen S, Liu J, Ouyang A. Efficacy and safety of omadacycline for the treatment of infectious diseases: a real-world, retrospective study of 2587 patients. Front Pharmacol. 2025;16:1706601. (Among 2587 patients treated with omadacycline at a single Chinese referral center, 82% resulted in clinical success while safety was considered “tolerable”, liver injury arising in 6.2%, although “most cases were mild to moderate” [no details provided]). 41341031
Yu M, Wang X, Wu S, Zhou Z, Liu Y, Chai Y. Comparison of efficacy and safety profiles between omadacycline and moxifloxacin in elderly patients with community-acquired pneumonia: a randomized, controlled trial. Clin Pharmacol Drug Dev. 2026;15:e1627. (Among 97 Chinese patients, aged 60 years or older, with community acquired pneumonia treated with omadacycline vs moxifloxacin iv for several days followed by oral formulations for a total of 7 to 14 days, the clinical success rate was 54% vs 27% while adverse event rates were similar [data not provided]). 41267642

## OTHER REFERENCE LINKS

1. Recent References on Omadacycline: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(omadacycline/AE)%20AND%20Human%5bMH%5d%20AND%20(%20drug-induced%20liver%20injury%20OR%20jaundice/CI%20OR%20bile%20duct%20diseases/CI%20OR%20liver%20OR%20liver%20diseases/CI)%20AND%20(%222008/1/1%22%5bEDat%5d:%222999/12/31%22%5bEDat%5d))

2. Trials on Omadacycline: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=omadacycline)